# Nelfinavir

## OVERVIEW

### Introduction

Nelfinavir is an antiretroviral protease inhibitor used in the therapy and prevention of human immunodeficiency virus (HIV) infection and the acquired immunodeficiency syndrome (AIDS). Nelfinavir can cause transient and usually asymptomatic elevations in serum aminotransferase levels and is a rare cause of clinically apparent, acute liver injury. In HBV or HCV coinfected patients, hepatic injury during antiretroviral therapy that includes nelfinavir may be a result of exacerbation of the underlying chronic hepatitis B or C, rather than a direct effect of the medication.

### Background

Nelfinavir (nel fin' a vir) is a nonpeptidic protease inhibitor that acts by binding to the catalytic site of the HIV protease, thereby preventing the cleavage of viral polyprotein precursors into mature, functional proteins that are necessary for viral replication. Nelfinavir was approved for use in the United States in 1997 for the therapy of HIV infection in both adults and children. Nelfinavir is available in tablets of 250 and 625 mg and as an oral suspension powder under the brand name Viracept. The recommended dosage of nelfinavir for adults is 1250 mg twice or 750 mg three times daily. Common side effects include nausea, diarrhea, gastrointestinal upset, fatigue and, with long term use, hyperlipidemia and lipodystrophy.

### Hepatotoxicity

Some degree of serum aminotransferase elevation occurs in a high proportion of patients taking nelfinavir containing antiretroviral regimens. Moderate-to severe elevations in serum aminotransferase levels (>5 times the upper limit of normal) are found in only 3% to 10% of patients, although rates may be higher in patients with HIV-HCV coinfection. These elevations are usually asymptomatic and self-limited and can resolve even with continuation of the medication. Clinically apparent acute liver injury due to nelfinavir is rare. The few cases that have been reported have arisen after 1 to 8 weeks of starting nelfinavir, and the pattern of serum enzyme elevations has not been reported, but is likely to have been hepatocellular (Case 1). Signs of hypersensitivity (fever, rash, eosinophilia) can occur as can autoantibody formation but these features are not very prominent. The acute liver injury due to nelfinavir is usually self-limited, but it can be severe, and isolated cases of acute liver failure have been reported to the sponsor, although not in great detail. In HBV or HCV coinfected patients, some instances appear to be due to exacerbation of the underlying chronic liver disease, perhaps as a result of sudden immune reconstitution. Nelfinavir therapy has not been clearly linked to lactic acidosis and acute fatty liver that is reported in association with several nucleoside analogue reverse transcriptase inhibitors used to treat HIV infection.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the clinical hepatotoxicity from nelfinavir is only partially known. Nelfinavir is extensively metabolized by the liver, largely by the cytochrome P450 system (CYP3A4), and toxic intermediates may be the cause of some liver injury. In patients with HIV infection who are coinfected with either HBV or HCV, initiation of potent antiretroviral therapy may be associated with flares of the underlying chronic hepatitis, which may be the result of reconstitution of the immune system, viral interactions or a direct effect of the drug.

### Outcome and Management

The severity of the liver injury from nelfinavir ranges from mild and transient enzyme elevations to more marked and symptomatic enzyme elevations and, rarely, to acute hepatitis which is usually self-limited, but can result in acute liver failure and death. Liver injury may be more common in persons without immune deficiency, such as patients receiving nelfinavir as a means of preventing HIV infection after acute exposure. Typically, improvements start within a few days of stopping therapy and recovery is usually rapid. Rechallenge may lead to recurrence and should be avoided. There is little evidence for cross reactivity to the hepatotoxicity of nelfinavir with other HIV protease inhibitors; most are proteomimetic and have little structural similarity. The exacerbation of hepatitis B or C that can occur with nelfinavir based antiretroviral therapies can be severe and lead to acute liver failure or progressive, end stage liver disease. Patients with HCV or HBV coinfection should be monitored prospectively for viral and serum aminotransferase levels and appropriate therapy instituted if possible.

References to nelfinavir are included with references to all the HIV protease inhibitors in the overview section of Protease Inhibitors (updated September 2017). Most of the HIV protease inhibitors in clinical use are proteinomimetic drugs and are structurally unrelated.

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Protease Inhibitors: Amprenavir, Atazanavir, Darunavir, Fosamprenavir, Indinavir, Lopinavir, Ritonavir, Saquinavir, Tipranavir

## CASE REPORT

### Case 1. Acute anicteric hepatitis during post-exposure prophylaxis with nelfinavir.

(Modified from: Trapé M, Barnosky S. Nelfinavir in expanded postexposure prophylaxis causing acute hepatitis with cholestatic features: two case reports. Infect Control Hosp Epidemiol 2001; 22: 333-4. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/11519908))

A 54 year old physician was injured while performing a liver biopsy on a patient coinfected with HIV and HCV and was started on a prophylactic regimen of zidovudine, lamivudine and nelfinavir. After 15 days, he developed nausea, diarrhea, fever, fatigue and muscle aches. The following day, he continued to have fever and diarrhea and developed abdominal pain. Physical examination revealed an enlarged and tender liver, but no rash, lymph node enlargement or signs of chronic liver disease. Laboratory tests results were not provided. All three antiviral medications were stopped, and symptoms promptly improved. One day later, zidovudine and lamivudine were restarted. Ten days after stopping nelfinavir, symptoms had resolved and the liver was no longer tender or enlarged. Four weeks after onset, laboratory tests were normal. He did not acquire either HIV or HCV infection.

#### Key Points

Medication: | Nelfinavir
Pattern: | Unknown (no ALT or alkaline phosphatase results)
Severity: | 2+ (jaundice, but no hospitalization)
Latency: | 15 days
Recovery: | Complete within 4 weeks
Other medications: | Zidovudine, lamivudine

#### Comment

Patients without HIV infection and with a normal immune system receiving antiretroviral therapy as a means of preventing HIV infection after acute exposure may be more susceptible to hepatic injury from protease inhibitors than patients with HIV and AIDS. Several protease inhibitors and nonnucleoside reverse transcriptase inhibitors have been implicated in severe cases of hepatotoxicity in persons receiving these agents as prophylaxis. Monitoring symptoms and routine serum enzymes is appropriate during antiretroviral prophylaxis, especially when using two or more agents. The absence of any liver test results in this report makes it difficult to judge the likelihood that the incident represented drug induced liver disease.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nelfinavir – Viracept®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Nelfinavir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nelfinavir | 159989-64-7 | C32-H45-N3-O4-S | Nelfinavir Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Nelfinavir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Nelfinavir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Nelfinavir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nelfinavir)